# Acute Fatty Liver with Lactic Acidosis and Hepatic Dysfunction

Description. Acute fatty liver with lactic acidosis and hepatic dysfunction is a dramatic and distinctive clinical syndrome associated with medications that affect mitochondrial function. The hallmark of the syndrome is hepatic microvesicular steatosis (small droplet fat) accompanied by lactic acidosis and clinical and laboratory features of hepatic failure, such as stupor, coma, encephalopathy, hyperammonemia, hypoglycemia and coagulopathy.

Latency to Onset. The onset of hepatic steatosis and lactic acidosis varies with the causative agent and pathophysiology of mitochondrial failure. Drugs that directly inhibit mitochondrial function or protein synthesis directly cause this syndrome within 7 to 28 days, as is typical with aspirin in Reye syndrome and intravenous tetracycline particularly when given to pregnant women. For agents that inhibit mitochondrial DNA synthesis and cause mitochondrial failure as a result of lack of replacement of mitochondria, such as the nucleoside analogues, this syndrome arises after 2 to 3 months of continuous therapy.

Symptoms. Initial symptoms are nonspecific and vague and include nausea, poor appetite, weight loss and abdominal discomfort. These prodromal symptoms precede evidence of hepatic injury by 1 to 4 weeks. With onset of lactic acidosis, shortness of breath and weakness arise followed by stupor and coma. Jaundice occurs late and is usually mild. Once lactic acidosis is present, this syndrome is life threatening.

Serum Enzyme Elevations. Serum aminotransferase levels are usually minimally elevated even with the onset of hepatic failure. Decrease in serum albumin, prolongation of prothrombin time, appearance of hyperammonemia, hypoglycemia and lactic acidosis often precede the appearance of jaundice, which tends to be late and mild-to-moderate in severity (bilirubin <10 mg/dL). The mitochondrial dysfunction often affects multiple organs and myopathy, neuropathy, pancreatitis and optic neuritis can be prominent (and, in some instances, overshadow the liver injury).

Drugs. Typical agents that cause hepatic steatosis and lactic acidosis include intravenous tetracycline, aspirin (in Reye syndrome), linezolid, and the d-nucleoside analogues, fialuridine, didanosine, stavudine and zidovudine.

Differential Diagnosis. The syndrome of microvesicular fatty liver with lactic acidosis and hepatic dysfunction is usually due to medications, but can occur spontaneously in patients with rare inherited forms of mitochondrial dysfunction (urea-cycle disorders). Lactic acidosis is also typical of ischemia and multiorgan failure and can be present in cases of acute liver failure.

Criteria for Definition. Elements important in diagnosis of acute fatty liver with lactic acidosis and hepatic dysfunction due to medications include:

1 Rise in serum lactate (confirmed on two samples)
2 Hepatic steatosis shown by liver biopsy or by imaging techniques
3 Rise in serum aminotransferase or alkaline phosphatase or bilirubin levels above 2 times the ULN
4 Decrease in serum albumin, or prolongation of prothrombin time or rise in serum ammonia levels.

The major differential diagnosis of the hepatic steatosis is alcoholic or nonalcoholic fatty liver disease and steatosis induced by sudden weight gain or corticosteroids. The differential diagnosis of lactic acidosis includes ischemia, shock and multiorgan failure. The overall clinical presentation, however, is quite distinct between these conditions and acute fatty liver with lactic acidosis and hepatic failure.

## Representative Cases

### Case 1. Liver injury, hyperlactatemia and pancreatitis induced by stavudine.

[Modified from: Bleeker-Rovers C, Kadir S, van Leusen R, Richter C. Hepatic steatosis and lactic acidosis caused by stavudine in an HIV-infected patient. Neth J Med 2000; 57: 190-3. PubMed Citation]

A 45 year old man with HIV infection developed nausea, vomiting and abdominal pain 3 months after starting stavudine (400 mg twice daily). He had been on didanosine (400 mg daily) and prednisone (5 mg daily) for more than 2 years and had previously received zidovudine. On physical examination, he was jaundiced and had right upper quadrant abdominal tenderness. Serum bilirubin was 14 mg/dL, alkaline phosphatase 400 U/L and ALT 300 U/L. Serum amylase levels were mildly elevated. Ultrasound showed changes compatible with fatty liver; percutaneous liver biopsy revealed macrovesicular steatosis and cholestatic hepatitis. Both didanosine and stavudine were stopped. The patient improved, and all tests were normal 3 weeks later. After recovery, stavudine was restarted in the same dose and, within a week, serum lactate levels increased from normal to 9.1 mmol/L, but serum aminotransferase levels did not change. Stavudine was stopped again and the patient remained well off of all antiretroviral therapy and had normal serum enzymes over the next year.

#### Key Points

Medication: | Stavudine (40 mg twice daily)
Pattern: | Cholestatic (R=1.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months
Recovery: | 3 weeks
Other medications: | Prednisone 5 mg daily, didanosine 400 mg daily

#### Comment

Stavudine was considered to be the most likely cause of the liver injury and hyperlactatemia, although didanosine may have contributed or increased the risk. He had received didanosine without problems for the previous two years, the liver injury arising only with the addition of stavudine. This syndrome appears to be rapidly reversible with withdrawal of nucleoside analogue therapy in the early stages of hyperlactatemia and liver injury.

### Case 2. Fatal lactic acidosis and hepatic steatosis after stavudine therapy.

[Modified from: Cornejo-Juáz P, Sierra-Madero J, Volkow-Fernáez P. Metabolic acidosis and hepatic steatosis in two HIV-infected patients of stavudine (d4T) treatment. Arch Med Res 2003; 34: 64-9. PubMed Citation]

A 45 year old woman with HIV infection developed worsening peripheral neuropathy followed by jaundice and severe abdominal pain, 5 months after changing her antiretroviral regimen from zidovudine and didanosine to nevirapine, stavudine, lamivudine and hydroxyurea. On admission, physical examination showed dehydration, jaundice and abdominal tenderness with tachypnea and tachycardia. Serum bilirubin was 14.3 mg/dL, ALT 45 U/L, alkaline phosphatase 835 U/L, amylase 968 U/L, lactate 14.3 mmol/ L and arterial pH 7.26. Tests for hepatitis B and C were negative. Abdominal ultrasound showed pancreatic edema and echogenicity of the liver suggestive of steatosis. Despite intensive medical support, she developed intractable lactic acidosis and multiorgan failure, dying within 48 hours of admission.

#### Key Points

Medication: | Stavudine (400 mg twice daily)
Pattern: | Cholestatic (R<1)
Severity: | 5+ (fatal)
Latency: | 5 months
Recovery: | None
Other medications: | Nevirapine, lamivudine, hydroxyurea; previously zidovudine, didanosine

#### Comment

Five months after stavudine was added to a chronic antiretroviral regimen, this patient developed severe liver injury and lactic acidosis that was rapidly fatal. Symptoms of neuropathy had been present for several weeks and diagnosis was delayed until severe lactic acidosis was present. The mitochondrial injury from nucleoside analogues can affect liver, pancreas, muscle and peripheral nerves singly or in combination.

### Case 3. Liver failure from intravenous tetracycline.

[Modified from: Robinson MJ, Rywlin AM. Tetracycline-associated fatty liver in the male. Report of an autopsied case. Am J Dig Dis 1970; 15: 857-62. PubMed Citation]

A 72 year old man treated for cystitis and diverticulitis with 10 days of iv tetracycline developed lactic acidosis and multiorgan failure. The patient had no previous history of liver disease or risk factors for hepatitis. When initially admitted to the hospital, he had fever, abdominal pain, leukocytosis and an abnormal urinalysis, but liver tests were normal (Table). He was treated with hydration and iv tetracycline in doses of 3 grams daily. His fever improved slowly but by day 4, liver tests were mildly abnormal and they had worsened by day 8. Colistin was added on day 6, and chloramphenicol was substituted for tetracycline on day 10. The following day, he developed progressive restlessness, stupor and respiratory failure. He had renal failure and severe acidosis and he died within hours of attempting resuscitation and dialysis. Autopsy showed an enlarged fatty liver with minimal inflammation and no obvious hepatocellular necrosis. Fat was also identified in renal tubular cells. There was marked ascites and hemorrhagic pancreatitis.

#### Key Points

Medication: | Tetracycline (3 grams iv daily for 10 days)
Pattern: | Hepatocellular
Severity: | 5+ (death from hepatic failure and lactic acidosis)
Latency: | 4 days
Recovery: | Fatal
Other medications: | Colistin and chloramphenicol (after onset of liver injury)

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 32 | 8 | 0.3 | Started iv tetracycline
4 | | 190 | 10 | 2.4 | BUN 39 mg/dL
8 | | 530 | 11.5 | 2.2 | Colistin added im every 12 hours
10 | | Tetracycline stopped; chloramphenicol started
11 | 1 | 1550 | 15 | 6.8 | BUN 105; CO2 11 mEq/L
Increasing stupor and respiratory failure, hemodialysis and resuscitative measures failed
Normal Values | | <40 | <13 | <1.2

#### Comment

Acute fatty liver caused by tetracycline was initially thought to occur only in pregnant women during the last trimester, but was subsequently reported to occur at other times during pregnancy, after delivery, in nonpregnant women, in men and even in children. The syndrome typically occurs after 3 to 10 days of relatively high doses of im or iv tetracycline. The case above is typical in demonstrating that the precipitous onset of symptoms is a late phenomenon and has a grim prognosis; symptoms are preceded by several days of worsening liver injury, although laboratory tests may be only mildly or moderately abnormal. Acute fatty liver is accompanied by minimal hepatic inflammation and liver cell necrosis and is a syndrome of mark mitochondrial failure, early appearance of hepatic synthetic dysfunction and lack of ATP to drive normal metabolism. The injury is not confined to the liver and renal failure and pancreatitis are common. As in this case, the immediate cause of death is typically multiorgan failure due to lactic acidosis or pancreatitis.

### Case 4. Reye syndrome in a child with juvenile rheumatoid arthritis.

[Modified from: Norman MG, Lowden JA, Hill DE, Bannayne RM. Encephalopathy and fatty degeneration of the viscera in childhood: II. Report of a case with isolation of influenza B virus. Canad Med Assoc J 1968; 99: 522-6. PubMed Citation]

A 9 year old girl with juvenile rheumatoid arthritis on salicylates developed nausea, vomiting and drowsiness and was admitted to hospital for suspected salicylate intoxication. However, blood salicylate levels were within the therapeutic range (17.5/mg/dL) and she developed progressive restlessness, confusion and ultimately coma. She had acidosis and hypoglycemia and was treated with intravenous fluids. Serum AST levels were normal on admission, but rose to 696 U/L which led to an emergency liver biopsy that showed microvesicular fatty change with no inflammation, fibrosis or architectural distortion. The liver was devoid of glycogen. Despite supportive care and artificial ventilation, she developed progressive coma, cerebral edema and died 72 hours after admission which was 5 days after initial symptoms of vomiting. Autopsy showed cerebral edema and steatosis in the liver with both macro- and microvesicular fat. Although there was no antecedent history of upper respiratory illness, she had complained of headaches for 2 weeks before onset and influenza B virus was isolated from the liver biopsy and from multiple tissues at autopsy.

#### Key Points

Medication: | Aspirin (salicylate levels maintained at 20 to 25 mg/dL)
Pattern: | Hepatocellular (acute fatty liver) (R=33)
Severity: | 5+ (death)
Latency: | 2 months from initiation of aspirin use, 1 day after onset of vomiting
Recovery: | None
Other medications: | Vitamins, throat lozenges and proprietary laxative

#### Laboratory Values

Days After Stopping | AST (U/L) | Alk P* (KAU/L) | Arterial pH | Glucose (mg/dL) | Other
0 | | | 7.25 | | Serum salicylate levels 17.5 mg/dL
1 | 35 | 27 | 6.80 | 25 | IV fluids initiated, bilirubin 1.2 mg/dL
2 | 696 | 12 | 7.51 | 155 | Ventilatory support, liver biopsy
3 | 475 | | 7.43 | >200
4 | 4 | | | | Death from cerebral edema
Normal | <35 | <20 | 7.40 | 70-115

* King Armstrong units.

#### Comment

A well described case of Reye syndrome arising in a child on chronic salicylate therapy for juvenile rheumatoid arthritis. This case was described before epidemiological data linked Reye syndrome with influenza B and aspirin and is strikingly prescient. The initial symptoms were probably due to lactic acidosis, and AST levels rose shortly thereafter. In cases with recovery, aminotransferase levels fall as rapidly as they had risen. Initially, liver tissue shows microvesicular fat and absence of glycogen as the liver cell uses glycolysis to compensate for the lack of ATP produced by mitochondria. When this mechanism fails, lactic acid levels rise and hepatocytes release enzymes triggered by apoptosis from mitochondrial and cell functional failure. These processes occur rapidly, even before aminotransferase and bilirubin levels rise (the latter being a product of hepatocellular failure).

### Case 5. Acute fatty liver and lactic acidosis from fialuridine.

[NIH Clinical Center]

In March 1993, a 43 year old man with chronic hepatitis B and glomerulonephritis was the initial patient enrolled in a clinical research protocol using fialuridine [FIAU], a newly developed oral nucleoside analogue with proven activity against hepatitis B virus (HBV) in vitro and in vivo. Serum levels of HBV DNA decreased rapidly on therapy (using a direct hybridization assay with a lower limit of detection of ~1 million copies/mL) and aminotransferase levels improved (Table). After 8 weeks of therapy, however, he complained of numbness and tingling in his fingers. Physical examination and nerve conduction tests were normal. When symptoms did not improve, fialuridine was stopped. He improved symptomatically but liver test and HBV DNA results returned towards pretreatment values. One week later (2 weeks after stopping fialuridine), he had the rapid onset of severe shortness and breath and weakness and was admitted with lactic acidosis, dehydration and shock. Serum aminotransferase levels were minimally increased, but he was jaundiced (bilirubin 5.8 mg/dL) and had features of hepatic failure with prothrombin time of 15.4 seconds, albumin 2.8 g/dL, ammonia 77 mmoL, and lactate levels of 18.8 mg/dL (normal <2.5). Hydration and treatment with sodium bicarbonate improved the acidosis, but lactate levels remained high. He developed worsening coagulopathy, ascites and hepatic encephalopathy and was transferred to a liver transplant center. There he was treated with an experimental hepatic assist device but lactate levels continued to rise. He underwent emergency liver transplantation 102 days after starting and 25 days after stopping fialuridine, but suffered primary graft nonfunction and died two days later with hemodynamic collapse and severe lactic acidosis (lactate levels 60.6 mg/dL). The explanted liver showed diffuse microvesicular and focal macrovesicular fat, severe cholestasis and ballooning hepatocellular degeneration.

#### Key Points

Medication: | Fialuridine (15 mg daily: 0.25 mg/kg)
Pattern: | Hepatocellular
Severity: | 5+ (death from hepatic failure and lactic acidosis)
Latency: | 3 months
Recovery: | Fatal
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | HBV DNA (M copies) | Bilirubin (mg/dL) | Other
0 | | 136 | 30.0 | 0.6 | Started on fialuridine
1 week | | 220 | <1.0 | 0.4
4 weeks | | 109 | <1.0 | 0.6
8 weeks | | 86 | <1.0 | 0.4
11 weeks | 0 | Fialuridine stopped because of symptoms of neuropathy
12 weeks | 6 days | 152 | 5.0 | 0.6
13 weeks | 17 days | 211 | 3.0 | 5.8 | Lactic acidosis and shock
14 weeks | 21 days | 120 | 3.0 | 17.4 | Transfer to Transplant Center
15 weeks | 25 days | 62 | | 20.0 | Emergency liver transplantation
Death from hemodynamic collapse with lactic acidosis
Normal Values | | <40 | | <1.2

* M=million copies by DNA hybridization.

#### Comment

Fialuridine [FIAU] was the first orally available nucleoside analogue developed as therapy for chronic hepatitis B, but was abandoned when it was found to cause fatal liver injury during a phase 2 trial being conducted at the National Institutes of Health. In preclinical studies, fialuridine showed no evidence of hepatotoxicity in several animal species. In small phase 1 trials in humans with chronic hepatitis B, 10 to 28 day courses of fialuridine were well tolerated and resulted in marked declines in HBV DNA levels and sustained remissions of disease in a proportion of patients. Administration of the medication beyond 8 weeks, however, led to a severe and inexorably progressive acute fatty liver with lactic acidosis and liver failure. Of the 17 patients enrolled in the study, 5 died of lactic acidosis, hepatic failure and pancreatitis, 2 recovered after emergency liver transplantation, and the remaining 10 survived (most had received fialuridine for less than two months). The case above was the initial patient enrolled whose acute presentation led to the immediate termination of the trial. The premonitory symptoms of numbness and tingling were due to peripheral neuropathy which was also caused by mitochondrial failure. Unlike stavudine, didanosine and intravenous tetracycline, fialuridine caused an irreversible lactic acidosis and hepatic failure and patients developed the progressive syndrome weeks and even months after stopping therapy. Two patients underwent successful liver transplantation despite severe lactic acidosis (which was partially controlled by continuous infusions of 20% glucose). Both patients survived transplantation without recurrence of hepatitis B and died 15 and 16 years later with normal liver function, the causes of death being colon cancer and melanoma.

## Histologic Images

Photomicrographs by

David E. Kleiner, MD, PhD

Laboratory of Pathology

National Cancer Institute

(See high resolution images)

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

The hepatocytes are swollen and pale. At this magnification the individual vacuoles cannot be seen. There are no confluent areas of necrosis and very little inflammation.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: The hepatocytes are swollen and pale. At this magnification the individual vacuoles cannot be seen. There are no confluent areas of necrosis and very little inflammation.

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

Under high magnification, some of the hepatocytes clearly have a foamy appearance due to the numerous tiny vacuoles filling the cytoplasm. In some cells, the vacuoles are so tiny that the cytoplasm has a pale granular appearance.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: Under high magnification, some of the hepatocytes clearly have a foamy appearance due to the numerous tiny vacuoles filling the cytoplasm. In some cells, the vacuoles are so tiny that the cytoplasm has a pale granular appearance.

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

A digitally enlarged micrograph demonstrating the fine vacuolation seen in microvesicular steatosis.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: A digitally enlarged micrograph demonstrating the fine vacuolation seen in microvesicular steatosis.

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

In addition to microvesicular steatosis, hepatocellular and canalicular cholestasis was seen (arrows). Depending on the amount of bile pigment present, the color of bile may vary from dark green‐brown to pink or red, as in this example.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: In addition to microvesicular steatosis, hepatocellular and canalicular cholestasis was seen (arrows). Depending on the amount of bile pigment present, the color of bile may vary from dark green‐brown to pink or red, as in this example.

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

In another case of fialuridine toxicity, the steatosis was mixed, with scattered cells showing large fat vacuoles characteristic of macrovesicular steatosis.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: In another case of fialuridine toxicity, the steatosis was mixed, with scattered cells showing large fat vacuoles characteristic of macrovesicular steatosis.

Microvesicular Steatosis due to Fialuridine Toxicity

Histologic Features to Note:

In this digitally magnified photo, the cell in the center has both a single large vacuole and numerous tiny vacuoles. Other cells in this case showed pure microvesicular steatosis.

(See high resolution image)

Microvesicular steatosis due to fialuridine toxicity: In this digitally magnified photo, the cell in the center has both a single large vacuole and numerous tiny vacuoles. Other cells in this case showed pure microvesicular steatosis.